# Trazodone

## OVERVIEW

### Introduction

Trazodone is a serotoninergic modulating antidepressant that is used in therapy of depression, aggressive behavior and panic disorder. Trazodone therapy can be associated with transient, usually asymptomatic elevations in serum aminotransferase levels and has been linked to rare instances of clinically apparent acute liver injury.

### Background

Trazodone (traz' oh done) is a triazolopyridine derivative whose mechanism of action is believed to be inhibition of serotonin reuptake and modulation of serotonin receptor activity, which results in increased levels and activity of serotonin. Trazodone was approved for use in major depressive disorder in the United States in 1981 and remains in wide use, with more than 22 million prescriptions being filled yearly. Trazodone is also used off-label for control of aggressive behavior, panic disorder, anxiety, insomnia, substance abuse, bulimia, schizophrenia and dementia. Trazodone has anxiolytic activity and normalizes sleep patterns, effects that have made trazodone one of the most frequently prescribed drugs for insomnia. Trazodone is available in tablets of 50, 75, 100, 150 and 300 mg in several generic forms and formerly under the brand name Desyrel. The recommended dosage for depression in adults is 150 mg in divided doses that can be increased in 50 mg amounts to a maximum of 600 mg daily. An extended release formulation is also available in 150 mg tablets (Oleptro) which is given once daily. It is typically given in single, bedtime lower doses for insomnia. Common side effects of trazodone are drowsiness, fatigue, dizziness, headache, dry mouth, blurred vision, nausea, decreased libido, increased appetite and weight gain. Uncommon but potentially severe adverse events include suicidal thoughts and behaviors, activation of mania, serotonin syndrome, cardiac arrhythmias, orthostatic hypotension, priapism and angle-closure glaucoma.

### Hepatotoxicity

Liver test abnormalities occur in a proportion of patients on trazodone, but elevations are usually modest and usually do not require dose modification or discontinuation. At least a dozen instances of acute, clinically apparent episodes of liver injury with marked liver enzyme elevations with or without jaundice have been reported in patients on trazodone. The onset of injury varies from a few days to 6 months and the pattern of serum enzyme elevations is usually hepatocellular, but mixed and cholestatic forms have also been described. Several cases have had immunoallergic features (rash, fever, eosinophilia), but these were not prominent. Autoimmune (autoantibodies) features are uncommon. Rare instances of acute liver failure and death from trazodone have been reported. Nefazodone, an antidepressant similar in structure and mechanism of action to trazodone, was approved for use in 1998, but is currently not commonly used because of multiple reports of acute hepatocellular injury, with a high mortality rate arising 2 weeks to 6 months after starting therapy.

Likelihood score: B (likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which trazodone causes liver injury is not known. Trazodone is extensively metabolized by the liver, mainly via the cytochrome P450 system (CYP3A4), and hepatotoxicity may be mediated by toxic intermediates of its metabolism. Trazodone is susceptible to multiple drug-drug interactions.

### Outcome and Management

The serum aminotransferase elevations that occur on trazodone therapy are usually self-limited and do not require dose modification or discontinuation of therapy. Rare instances of acute liver failure and chronic hepatitis have been attributed to trazodone therapy. Persons with intolerance to trazodone may have similar reactions to other antidepressants, and careful monitoring is warranted if other such agents are used.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass: Nefazodone

## CASE REPORT

### Case 1. Acute hepatitis due to trazodone.(1)

A 38 year old woman with rheumatoid arthritis developed itching followed by jaundice approximately 18 months after starting trazodone. She was also receiving prednisone (10 mg daily), methotrexate, hydroxychloroquine, nabumetone, propoxyphene, folate, birth control pills and alendronate, but had been on this regimen for many years. She had no history of liver disease or known risk behaviors for acquiring hepatitis and did not drink alcohol. On examination, she was jaundiced but had no rash, fever or signs of chronic liver disease. Laboratory results showed a bilirubin of 11.0 mg/dL with marked elevations in serum aminotransferase levels (Table). Her liver tests had been normal on routine testing several months previously. Tests for hepatitis A, B and C were negative as were autoantibodies. An abdominal ultrasound showed no evidence of biliary obstruction. A liver biopsy showed intrahepatic cholestasis, modest inflammation, and ballooning degeneration but no fat or fibrosis. Trazodone was stopped, and she began to improve rapidly. She was discharged from the hospital, but one week later restarted trazodone. After two days she had a return of her symptoms and jaundice. Within two weeks of stopping trazodone for the second time, she had no symptoms of liver disease and her liver tests were near-normal.

#### Key Points

Medication: | Trazodone
Pattern: | Hepatocellular (R=5.8)
Severity: | 3+ (jaundice, hospitalization)
Latency: | Initially 18 months, with rechallenge 3 days
Recovery: | Within 1 month
Other medications: | Prednisone, methotrexate, hydroxychloroquine, nabumetone, propoxyphene, folate, birth control pills, alendrolate.

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
12 months | | 13 | 64 | 0.8 | Routine testing
Onset of pruritus and jaundice 18 months after starting trazodone
18 months | 0 | 1092 | 206 | 11.0
| 3 days | 786 | 191 | 8.7
Discharged from hospital and restarted trazodone shortly thereafter
| 10 (0) days | 1476 | 259 | 10.3
| 15 (5) days | 466 | 202 | 3.3
| 19 (9) days | 146 | 154 | 2.4
| 23 (13) days | 55 | 108 | 1.6
| 30 (20) days | 43 | 93 | 1.4
| 51 (41) days | 17 | 71 | 0.9
Normal Values | | <48 | <125 | <1.2

* Numbers in parentheses indicate the days after stopping the second time.

#### Comment

Trazodone has been linked to rare cases of hepatic injury. The onset of injury is generally after several months and is typically hepatocellular, although cases with a shorter latency and with a cholestatic pattern of serum enzyme elevations have been described. In this case, the long latency period was atypical of trazodone and not characteristic of drug induced liver disease in general. Furthermore, the patient was taking other potentially hepatotoxic drugs (methotrexate, nabumetone). What makes the likelihood of trazodone being the cause of the injury was the inadvertent rechallenge that led to a rapid worsening of the injury. Furthermore, the liver biopsy showed no evidence of methotrexate injury and had changes that were considered typical of drug induced liver injury. The hepatic injury rapidly resolved with stopping therapy.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trazodone – Generic, Desyrel®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=TRAZODONE+HYDROCHLORIDE)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Trazodone | 19794-93-5 | C19-H22-Cl-N5-O

## CITED REFERENCES

1 Fernandes NF, Martin RR, Schenker S. (2000). Trazodone-induced hepatotoxicity: a case report with comments on drug-induced hepatotoxicity. Am J Gastroenterol.

## ANNOTATED BIBLIOGRAPHY

References updated: 26 February 2020

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999; trazodone is listed as potentially causing either cholestatic or hepatocellular injury having been implicated in at least 6 cases, including instances of chronic hepatitis).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants mentions that trazodone can cause immunoallergic liver injury with a latency of a few days to 1.5 year and with variable patterns of enzyme elevations).
O'Donnell JM, Bies RR, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-78. (Textbook of pharmacology and therapeutics).
Chu AG, Gunsolly BL, Summers RW, Alexander B, McChesney C, Tanna VL. (1983). Trazodone and liver toxicity. Ann Intern Med. (63 year old man developed rash and asymptomatic liver test abnormalities 4 weeks after starting trazodone [bilirubin normal, ALT 55 rising to 211 U/L, Alk P 139 to 535 U/L], serum enzymes worsening for a week after stopping therapy before rapidly falling to normal).
Sheikh KH, Nies AS. (1983). Trazodone and intrahepatic cholestasis. Ann Intern Med. (71 year old woman developed jaundice 2 weeks after starting trazodone [bilirubin 12 mg/dL, AST 780 U/L, Alk P 1310 U/L], bilirubin peaking 2 weeks later [29 mg/dL], but injury ultimately resolved within 8 weeks of stopping).
Longstreth GF, Hershman J. (1985). Trazodone-induced hepatotoxicity and leukonychia. J Am Acad Dermatol. (57 year old woman developed jaundice 6 months after starting trazodone [bilirubin 14.8 mg/dL, AST 277 U/L, Alk P 161 U/L, protime 29 sec], resolving within 5 weeks of stopping, but minor AST and Alk P elevations persisted for 6 months).
Rongioletti F, Rebora A. (1986). Drug eruption from trazodone. J Am Acad Dermatol. (71 year old woman developed fever and rash several months after starting trazodone [bilirubin normal, ALT 81 U/L, Alk P 177 U/L, eosinophils 7%, ANA negative], resolving within 2 weeks of stopping).
Beck PL, Bridges RJ, Demetrick DJ, Kelly JK, Lee SS. (1993). Chronic active hepatitis associated with trazodone therapy. Ann Intern Med. (75 year old woman developed jaundice 7 months after starting trazodone [bilirubin 17.9 mg/dL, ALT 933 U/L, Alk P 144 U/L], biopsy showing chronic hepatitis, rapid clinical improvement, but bilirubin was raised for 6 months after stopping).
Hull M, Jones R, Bendall M. (1994). Fatal hepatic necrosis associated with trazodone and neuroleptic drugs. BMJ. (72 year old woman developed ALT elevations [107 U/L] 10 weeks after starting trazodone, trifluoperazine and lithium, developing jaundice at 18 weeks and dying 2 months later).
Robinson DS, Roberts DL, Smith JM, Stringfellow JC, Kaplita SB, Seminara JA, Marcus RN. (1996). The safety profile of nefazodone. J Clin Psychiatry. (Pooled analysis of 3500 patients on nefazodone in clinical trials; most common side effects were nausea, somnolence, dry mouth, dizziness, constipation and asthenia; 12% stopped drug for side effects vs 7.5% on placebo, 10.5% fluoxetine and 22% imipramine; no excess weight gain or abnormal laboratory tests vs placebo; no deaths or severe side effects due to liver injury and no mention of ALT elevations).
Lucena MI, Andrade RJ, Gomez-Outes A, Rubio M, Cabello MR. (1999). Acute liver failure after treatment with nefazodone. Dig Dis Sci. (73 year old woman developed abdominal pain 7 weeks after starting nefazodone [bilirubin 17.1 mg/dL, ALT 834 U/L, Alk P 115 U/L, protime 15 sec], with progressive liver failure and death 4 weeks after presentation).
Aranda-Michel J, Koehler A, Bejarano PA, Poulos JE, Luxon BA, Khan CM, Ee LC, et al. (1999). Nefazodone-induced liver failure: report of three cases. Ann Intern Med. (Three women, ages 54, 16 and 57 years, developed jaundice 8, 3 and 6 months after starting nefazodone [bilirubin 34.0, 22.5 and 11.8 mg/dL, ALT 2040, 1345 and 1625 U/L, Alk P 97, 206 and 273 U/L], biopsies showing massive and centrilobular necrosis; 1 died, 1 recovered and 1 was transplanted).
van Battum PL, van de Vrie W, Metselaar HJ, Verstappen VM, Zondervan PE, de Man RA. (2000). Ned Tijdschr Geneeskd.
Schirren CA, Baretton G. (2000). Nefazodone-induced acute liver failure. Am J Gastroenterol. (52 year old man developed jaundice 5-6 weeks after starting nefazodone with ascites and liver failure requiring liver transplantation 6 weeks after presentation; explant showed massive hepatic necrosis).
Eloubeidi MA, Gaede JT, Swaim MW. (2000). Reversible nefazodone-induced liver failure. Dig Dis Sci. (46 year old woman developed fatigue followed by jaundice ~4 months after starting nefazodone [bilirubin 14.5 mg/dL, ALT 456 U/L, Alk P 158 U/L], resolving within 4 months of stopping).
Fernandes NF, Martin RR, Schenker S. (2000). Trazodone-induced hepatotoxicity: a case report with comments on drug-induced hepatotoxicity. Am J Gastroenterol. (39 year old woman developed jaundice 18 months after starting trazodone [bilirubin 11.0 mg/dL, ALT 1092 U/L and Alk P 206 U/L], improving rapidly upon stopping, but recurring with inadvertent rechallenge: Case 1).
Rettman KS, McClintock C. (2001). Hepatotoxicity after short-term trazodone therapy. Ann Pharmacother. (46 year old man with HIV-HCV co-infection had onset of symptoms of hepatitis within 5 days of entering cocaine detoxification program and starting trazodone [bilirubin 2.1 mg/dL, ALT 2581 U/L, Alk P 342 U/L], resolving rapidly upon stopping).
Ehrentraut S, Rothenhäusler HB, Gerbes AL, Rau HG, Thiel M, Schirren CA, Kapfhammer HP. (2002). Nervenarzt. (52 year old man developed acute liver failure 6 weeks after starting nefazodone [bilirubin 13.9 mg/dL, ALT 1947 U/L, GGT 88 U/L], progressing to hepatic failure requiring liver transplantation, dying of subsequent complications).
Stewart DE. (2002). Hepatic adverse reactions associated with nefazodone. Can J Psychiatry. (Analysis of Canadian Adverse Drug Reaction database found 32 cases of liver injury associated with nefazodone with onset after 1 week to 2 year, mostly within 6 months, 3 with hepatic failure).
Carvajal García-Pando A, García del Pozo J, Sánchez AS, Velasco MA, Rueda de Castro AM, Lucena MI. (2002). Hepatotoxicity associated with the new antidepressants. J Clin Psychiatry. (Analysis of cases of hepatotoxicity from antidepressants in Spanish Pharmacovigilance System from 1989-1999, identified 99 cases; among SSRIs, 26 due to fluoxetine, 14 paroxetine, 6 fluvoxamine, 5 sertraline, 3 venlafaxine and 2 citalopram; among tricyclics, 16 clomipramine 7 amitriptyline, 6 imipramine; among miscellaneous, 3 nefazodone and 1 trazodone; but all similar in rate ~1-3 per 100,000 patient-years of exposure, except for nefazodone=29/100,000).
Lucena M, Carvajal A, Andrade R, Velasco A. (2003). Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; SSRIs are less likely to cause injury than tricyclics and MAO inhibitors; range of presentations, typically self-limited and rapid recovery; no hallmarks of hypersensitivity).
Choi S. (2003). Nefazodone (Serzone) withdrawn because of hepatotoxicity. CMAJ. (Editorial announcing withdrawal of nefazodone in Canada; 51 Canadian reports of adverse hepatic events, 2 requiring transplant).
Tzimas GN, Dion B, Deschênes M. (2003). Early onset, nefazodone-induced fulminant hepatic failure. Am J Gastroenterol. (Two cases of acute liver failure in 61 and 46 year olds, with onset of jaundice 3 and 4 weeks after starting nefazodone with liver failure and encephalopathy, one requiring liver transplant and one with spontaneous survival).
Spigset O, Hägg S, Bate A. (2003). Hepatic injury and pancreatitis during treatment with serotonin reuptake inhibitors: data from the World Health Organization (WHO) database of adverse drug reactions. Int Clin Psychopharmacol. (Among 27,542 reports of hepatic injury in WHO database, 786 were related to SSRIs [3%], including citalopram 42, fluoxetine 222, fluvoxamine 54, paroxetine 191, sertraline 112, nefazodone 91 and venlafaxine 74, only nefazodone has an excess of hepatic reports in relationship to total reports).
Sánchez Ruiz JC, González López E, Aparicio Tijeras C, Ezquerra Gadea J. (2004). Aten Primaria. (60 year old was found to have abnormal liver tests without symptoms 6 months after starting trazodone [bilirubin 1.3 mg/dL, ALT 218 U/L, GGT 96 U/L], abnormalities resolving rapidly upon stopping).
Conway CR, McGuire JM, Baram VY. (2004). Nefazodone-induced liver failure. J Clin Psychopharmacol. (51 year old man developed jaundice and confusion 7 months after starting nefazodone and 1 week after a dose increase [bilirubin 1.7 mg/dL, ALT 1964 U/L, Alk P 96 U/L], resolving rapidly upon stopping).
Degner D, Grohmann R, Kropp S, Rüther E, Bender S, Engel RR, Schmidt LG. (2004). Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry. (Analysis of adverse drug reactions reported from 1993-2000 in 35 psychiatric hospitals; 0.7% of SSRI recipients had a severe adverse event; hepatic in 0.05%).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al., Spanish Group for the Study of Drug-Induced Liver Disease. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology. (Reports to a Spanish network found 461 cases of drug induced liver disease, antidepressants accounting for 23 cases [5%]).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports; no antidepressant ranked among the top 21 agents that were linked to at least 50 cases each).
Kostrubsky SE, Strom SC, Kalgutkar AS, Kulkarni S, Atherton J, Mireles R, Feng B, et al. (2006). Inhibition of hepatobiliary transport as a predictive method for clinical hepatotoxicity of nefazodone. Toxicol Sci. (Nefazodone, unlike trazodone, is a potent inhibitor of the bile salt export protein [BSEP] in cell culture).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 3 were attributed to paroxetine and 3 to fluoxetine, with a relative risk of injury to rate of use in the population of 3.0 and 1.8, respectively).
DeSanty KP, Amabile CM. (2007). Antidepressant-induced liver injury. Ann Pharmacother. (Review of drug induced liver injury and reports of injury from MAO inhibitors, SSRIs, tricyclics and atypical agents).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, antidepressants accounted for 12 cases [4%]: duloxetine [6], bupropion [2], fluoxetine [2], amitriptyline [1], sertraline [1]; no mention of trazodone).
Detry O, Delwaide J, De Roover A, Hans MF, Delbouille MH, Monard J, Honore P. (2009). Fulminant hepatic failure induced by venlafaxine and trazodone therapy: a case report. Transplant Proc. (48 year old woman developed jaundice and liver failure, and underwent liver transplantation, following combined therapy of venlafaxine and trazodone for 4 months).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, 3 of which were linked to antidepressants: one each for nefazodone, fluoxetine and venlafaxine).
Sedky K, Nazir R, Joshi A, Kaur G, Lippmann S. (2012). Which psychotropic medications induce hepatotoxicity?. Gen Hosp Psychiatry. (Review of the hepatotoxicity of psychotropic drugs in common use, mentions that nefazodone has a “black box” warning and that liver failure occurs at a rate of 1:250,000-300,000 patient-years of exposure; no mention of trazodone).
Park SH, Ishino R. (2013). Liver injury associated with antidepressants. Curr Drug Saf. (Review of drug induced liver injury due to antidepressants including trazodone and nefazodone).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to trazodone).
Montastruc F, Scotto S, Vaz IR, Guerra LN, Escudero A, Sáinz M, Falomir T, et al. (2014). Hepatotoxicity related to agomelatine and other new antidepressants: a case/noncase approach with information from the Portuguese, French, Spanish, and Italian pharmacovigilance systems. J Clin Psychopharmacol. (Among adverse event reports attributed to antidepressants submitted to 4 European pharmacovigilance databases, 3300 [10%] were for hepatotoxicity, rates being highest for agomelatine [14.6%], but was not above average for trazodone, 1.0% to 4.9%]).
Voican CS, Corruble E, Naveau S, Perlemuter G. (2014). Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry. (Review of the hepatotoxicity of antidepressants mentions that aminotransferase elevations arise in 0.5-3.0% of patients, being highest with MAO inhibitors and lower with SSRIs; all antidepressants have the potential to cause liver injury but is highest with nefazodone, imipramine, amitriptyline, duloxetine, bupropion, trazodone, and agomelatine).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, only one was due to an antidepressant [amitriptyline] and none to trazodone).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 [15%] were attributed to antidepressants, most frequently to duloxetine [n=7], bupropion [n=4], escitalopram [n=3], and 1 each for imipramine, fluoxetine, nefazodone and trazodone).
Gahr M, Zeiss R, Lang D, Connemann BJ, Hiemke C, Schönfeldt-Lecuona C. (2016). Drug-Induced Liver Injury Associated with antidepressive psychopharmacotherapy: an explorative assessment based on quantitative signal detection using different MedDRA terms. J Clin Pharmacol. (Using data on adverse drug reaction reports from the Uppsala Monitoring Center of WHO, there were higher relative hepatotoxicity reports for nefazodone, agomelatine, many tricyclics and mirtazapine).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. (2016). Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol. (Among 184,234 psychiatric inpatients from 80 hospitals, 149 cases [0.08%] of drug induced liver injury were reported but only one of them was attributed to trazodone).
Chen VC, Lin CF, Hsieh YH, Liang HY, Huang KY, Chiu WC, Lee Y, McIntyre RS, et al. (2017). Hepatocellular carcinoma and antidepressants: a nationwide population-based study. Oncotarget. (Among almost 50,000 cases of hepatocellular carcinoma registered in the Taiwan National Health Insurance Research Database, the rate of antidepressant use was lower than in approximately 250,000 matched controls from the database).
Bunchorntavakul C, Reddy KR. (2017). Drug hepatotoxicity: newer agents. Clin Liver Dis. (Review of hepatotoxicity of recently approved medications mentions that liver injury in recently approved agents and only rare instances have been linked to antidepressant use, highest rates associated with duloxetine).
Carvalhana S, Oliveira A, Ferreira P, Resende M, Perdigoto R, Barroso E. (2017). Acute liver failure due to trazodone and diazepam. GE Port J Gastroenterol. (63 year old man developed acute liver failure 3 months after starting trazodone and diazepam [bilirubin 12.0 mg/dL, ALT 4638 U/L, Alk P 122 U/L, INR 1.84], with worsening liver failure and transplant two weeks later).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al., DILI-IT Study Group. (2018). Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf. (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an Italian prospective study between 2010 and 2014, 17 had been exposed to antidepressants including citalopram [n=4], sertraline [n=3], amitriptyline [n=3] and paroxetine [n=2], and trazodone [n=1], and another was exposed to both trazodone and mirtazapine).
Billioti de Gage S, Collin C, Le-Tri T, Pariente A, Bégaud B, Verdoux H, Dray-Spira R, et al. (2018). Antidepressants and hepatotoxicity: a cohort study among 5 million individuals registered in the French National Health Insurance Database. CNS Drugs. (Using the French National Health Insurance Database, 382 serious liver injuries were found in approximately 5 million persons initiating antidepressant therapy, rates being 32.8 per 100,000 with mirtazapine, 22.2 with venlafaxine, 19.2 for SSRIs and 12.6 with duloxetine; trazadone is not specifically discussed).
(2019). Drugs for anxiety disorders. Med Lett Drugs Ther. (Concise review of drugs for anxiety including SSRIs, SNRIs and benzodiazepines including mechanism of action, clinical efficacy, safety and costs; does not mention ALT elevations or hepatotoxicity).
Pladevall-Vila M, Pottegård A, Schink T, Reutfors J, Morros R, Poblador-Plou B, Timmer A, et al. (2019). Risk of acute liver injury in agomelatine and other antidepressant users in four European countries: a cohort and nested case-control study using automated health data sources. CNS Drugs. (Analysis of data sources from 4 European countries identified 3.2 million persons initiating antidepressant therapy among whom there was no increased risk for acute liver injury for agomelatine compared to citalopram, an SSRI with a low rate of hepatotoxicity).
Schwasinger-Schmidt TE, Macaluso M. (2019). Other antidepressants. Handb Exp Pharmacol. (Review of the pharmacology of antidepressants mentions that the common side effects of trazodone are drowsiness, dizziness and dry mouth but does not mention hepatotoxicity or ALT elevations).
(2020). Drugs for depression. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for depression; hepatotoxicity is mentioned only for nefazodone [now rarely used because of severe hepatotoxicity] and duloxetine [in heavy drinkers]).

## OTHER REFERENCE LINKS

1 Recent References on Trazodone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=trazodone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Trazodone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=trazodone)